# Nivolumab

## OVERVIEW

### Introduction

Nivolumab is a human monoclonal antibody to programmed cell death receptor 1 (PD-1), which acts as a checkpoint inhibitor and is used in the immunotherapy of several forms of advanced or metastatic cancer. Nivolumab like other checkpoint inhibitors has major side effects and particularly immune related conditions, including acute hepatocellular and cholestatic liver injury which can be serious and even life threatening.

### Background

Nivolumab (nye vol' ue mab) is a human recombinant monoclonal immunoglobulin G4 antibody to the programmed cell death receptor-1 (PD-1), which has distinctive immunomodulatory activity and is used as a checkpoint inhibitor in cancer immunotherapy. PD-1 is an important checkpoint molecule that modulates and down regulates T cell responses. Inhibition of PD-1 receptors on the surface of activated T cells prevents the down regulation of activation and proliferation of T cells by the programmed cell death pathway. Because PD-1 receptor engagement is prevented by nivolumab, T cell responses remain activated. The subsequent enhancement of cytotoxic reactivity may play a beneficial role in cancer immunotherapy by breaking immunological tolerance to cancer cell associated antigens. In several large multicenter studies, nivolumab therapy resulted in a prolongation of survival in patients with advanced, metastatic or unresectable malignant melanoma, and a proportion of patients had a long term remission. Nivolumab was approved for use in advanced melanoma in the United States in 2014. Indications were subsequently extended to many other forms of solid tumors including non-small cell lung cancer (NSCLC), renal cell, hepatocellular, urothelial, colorectal, gastric, esophageal and head and neck carcinoma, Hodgkin disease, and pleural mesothelioma. Nivolumab is available in liquid solution in multiple sizes of single use vials of 10 mg/mL under the brand name Opdivo. The dose and regimen varies by indication, but is typically 240 mg every 2 weeks or 480 mg every 4 weeks. The combination of nivolumab with other chemotherapeutic agents is often recommended, particularly its combination with ipilimumab, a monoclonal antibody to CTLA-4, another checkpoint molecule. This combination, which was first approved as combination immunotherapy for malignant melanoma in 2015, continues to be commonly used.

Side effects of nivolumab are common and can include fatigue, headache, musculoskeletal pain, arthralgia, abdominal pain, diarrhea, nausea, vomiting, decreased appetite, weight loss, fever, cough, dyspnea, pruritus, and rash. Importantly, as a result of immune enhancement, between 15% and 25% of nivolumab treated patients develop immune related side effects, including enterocolitis, dermatitis, endocrinopathy, pneumonitis, neuropathy, nephritis and hepatitis. Most of these reactions respond to immunosuppressive therapy, but some have resulted in fatalities and some have required permanent discontinuation of checkpoint inhibitor therapy and long term immunosuppressive therapy. These immune related adverse events are more frequent with combination therapy of nivolumab with ipilimumab. Baseline screening and regular monitoring for these adverse events during nivolumab therapy is recommended. Early recognition and prompt management of side effects is an integral component of proper use of nivolumab and other checkpoint inhibitors such as ipilimumab and pembrolizumab. Checkpoints inhibitors should be used only by health care professionals with training in immunotherapy and experience in management of the side effects of immunomodulatory agents. Other rare but potentially severe adverse effects of nivolumab include infusion hypersensitivity reactions and embryo-fetal toxicity.

### Hepatotoxicity

Mild-to-moderate serum aminotransferase elevations are not uncommon (20% to 30%) during nivolumab therapy, but are usually self-limited and resolve even with continuing cyclic therapy. These rates of serum enzyme elevations are similar to those with other forms of chemotherapy for advanced malignancies. Serum ALT elevations above 5 times the upper limit of normal (ULN) occur in 1% to 4% of patients and generally lead to temporary discontinuation. Importantly, in 1% to 2% of patients serum enzyme elevations evolve into an immune mediated liver injury that can be clinically apparent and can be severe. The onset of injury is usually after 2 to 4 cycles or 1 to 3 months after starting treatment. The pattern of enzyme elevation is usually hepatocellular but can be mixed or even cholestatic. Liver histology typically demonstrates a panlobular hepatitis with focal or confluent necrosis and prominent lymphocytic infiltrates of activated T cells, compatible with an immune mediated hepatic injury. More severe forms of hepatitis may demonstrate centrilobular (zone 3) necrosis. Despite features of immune related liver injury, autoantibodies are generally not present and immunoglobulin levels are normal. Because of the serious nature of the liver injury, monitoring with routine liver tests (including alkaline phosphatase) is recommended for patients who receive checkpoint inhibitor therapy. Treatment with corticosteroids generally results in a rapid improvement and allows their discontinuation within 1 to 2 months. In some instances, however, the clinical and biochemical response is inadequate, calling for addition of a second immunosuppressive agent such as azathioprine, mycophenolate mofetil, tacrolimus, infliximab or antithymocyte globulin. Restarting nivolumab or another checkpoint inhibitor after resolution of the hepatic injury is sometimes possible, but can result in recurrence of injury and has not been shown to improve outcome of the cancer chemotherapy.

A proportion of patients receiving nivolumab develop cholestatic rather than hepatocellular liver injury. Cholestatic forms of immune mediated liver injury generally arise later than the hepatocellular forms, (after 3 to 10 cycles) and are often accompanied by abdominal pain and jaundice. Alkaline phosphatase levels are markedly elevated while aminotransferase levels are only modestly increased. Imaging studies may show irregular dilatation of the intra- and/or extra-hepatic bile ducts and thickening of the gall bladder and bile duct walls, but without evidence of frank obstruction. Liver biopsy shows portal inflammation and bile duct injury and endoscopic biopsy of the bile duct epithelium shows inflammation and scarring. The general features suggest a secondary form of sclerosing cholangitis referred to as checkpoint inhibitor cholangiopathy. Therapy with corticosteroids may improve alkaline phosphatase and bilirubin levels but rarely leads to complete recovery, and long term cholestasis and hepatic failure can occur. Some patients with a cholestatic form of immune related hepatitis do not manifest the large bile duct changes but demonstrate loss and paucity of the smaller, intrahepatic portal bile ducts resulting in a vanishing bile duct syndrome similar to primary biliary cholangitis (PBC).

The effects of PD-1 inhibition on chronic hepatitis B are not well defined but convincing examples of reactivation of hepatitis B have been described with nivolumab. Most cases have occurred in patients with preexisting HBsAg, but rare instances were reported in individuals suspected of having with anti-HBc without HBsAg. Thus, screening patients for HBsAg, anti-HBc and anti-HBs is appropriate before initiating immunotherapy with checkpoint inhibitors. Patients with HBsAg should be considered for prophylaxis with an antiviral agent with potent activity against HBV such as entecavir or tenofovir. In patients with anti-HBc without HBsAg, monitoring and close attention to liver test abnormalities is probably adequate if antiviral therapy can be introduced rapidly for early evidence of reactivation. There has not been adequate experience with nivolumab in regard to the risk of reactivation of hepatitis B to provide rates of reactivation with and without antiviral prophylaxis.

Likelihood score: A (well known cause of immune mediated liver injury and likely cause of reactivation of hepatitis B).

### Mechanism of Injury

The mechanism of liver injury due to nivolumab is likely to be immunologically mediated and is usually at least partially responsive to corticosteroid or immunosuppressive therapy. Liver biopsies in cases of hepatocellular injury and bile duct epithelial cell biopsies in cholangiopathic injury demonstrate necrosis and inflammatory cell infiltration with cytotoxic CD8+ T cells, suggesting that the checkpoint inhibition allowed for activation of T cells directed at hepatocyte or cholangiocyte cell surface antigens.

### Outcome and Management

Guidelines for management of patients receiving nivolumab recommend monitoring of liver tests and interrupting therapy for patients who develop serum aminotransferase elevations above 3 times the upper limit of normal (ULN) and discontinuing treatment for values above 8 times the ULN in patients without preexisting abnormalities or tumor involvement of the liver (in whom elevations of 5 and 10 times the ULN are used). Corticosteroid therapy can be considered for patients with high or persistent ALT elevations or if symptoms or jaundice arise, initiating therapy with high dose intravenous methylprednisolone and switching to oral prednisone after 1 to 2 days, continuing tapering doses for at least 30 days.

Most cases of liver injury due to nivolumab resolve with discontinuation and prompt institution of immunosuppressive therapy which can be discontinued in 1 to 3 months. In some more protracted and resistant instances, corticosteroids have only a limited effect and adding a second agent is needed. Mycophenolate mofetil or azathioprine are most commonly recommended. Other immunosuppressive agents that have been reported to be beneficial include antithymocyte globulin, tacrolimus, infliximab and cycloserine. In refractory cases, immunosuppressive therapy may be needed long term. The few fatal cases due to checkpoint inhibitors have typically occurred in patients who have cholestatic forms of liver injury or have other severe immune-related adverse events (Stevens Johnson syndrome, capillary leak syndrome). Restarting nivolumab after severe liver injury requiring corticosteroid therapy can be followed by recurrence of liver injury and is not recommended. Switching to other checkpoint inhibitors (ipilimumab or anti-PD-L1 inhibitors) is more likely to be tolerated. Interestingly, survival rates do not seem to be improved by re-introduction of checkpoint inhibitor therapy after severe immune related adverse events. Thus, restarting therapy should be undertaken only after careful evaluation of the residual cancer status.

Drug Class: Antineoplastic Agents, Monoclonal Antibodies, Checkpoint Inhibitors

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Nivolumab – Opdivo®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Nivolumab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Nivolumab | 946414-94-4 | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 23 June 2022

Abbreviations used: CPI, checkpoint inhibitor; CTLA-4, cytotoxic T lymphocyte associated antigen 4; HCC, hepatocellular carcinoma; irAE, immune related adverse event; PD-1, programmed cell death receptor 1; PD-L1, programmed cell death receptor ligand-1; NSCLC, non-small cell lung cancer; SCLC, small cell lung cancer.

Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway-targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Danan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
FDA. https://www.accessdata.fda.gov/scripts/cder/daf/index.cfm?event=overview.process&ApplNo=125554 (FDA website with current and previous product labels and the 2015 medical review of the new drug application for nivolumab).
Phan GQ, Yang JC, Sherry RM, Hwu P, Topalian SL, Schwartzentruber DJ, Restifo NP, et al. (2003). Cancer regression and autoimmunity induced by cytotoxic T lymphocyte-associated antigen 4 blockade in patients with metastatic melanoma. Proc Natl Acad Sci U S A. (Initial study of anti-CTLA-4 therapy in 14 patients with melanoma, 6 of whom developed clinically apparent immune adverse reactions including one with hepatitis arising after the third infusion [ALT 6820 U/L], resolving over the ensuing 4 months with corticosteroid therapy: Case 1).
Kleiner DE, Berman D. (2012). Pathologic changes in ipilimumab-related hepatitis in patients with metastatic melanoma. Dig Dis Sci. (Clinical and histological features of 5 patients with liver injury due to ipilimumab; 3 men and 2 women, ages 43 to 76 years, arising after 2-4 courses, 39-71 days after initial dose [peak bilirubin 1.5-5.1 mg/dL, ALT 326-3070 U/L, Alk P 206-427 U/L], only one had autoantibodies, resolving with immunosuppressive therapy within 1-4 months; one had recurrence on rechallenge; liver biopsies showed acute hepatitis usually with prominent inflammation, interface hepatitis and confluent necrosis: Case 1).
Topalian SL, Hodi FS, Brahmer JR, Gettinger SN, Smith DC, McDermott DF, Powderly JD, et al. (2012). Safety, activity, and immune correlates of anti-PD-1 antibody in cancer. N Engl J Med. (Among 296 patients with advanced cancers [melanoma, NSCLC, renal, prostate and colorectal] treated with 1 of 5 doses of nivolumab every 2 weeks, response rates were highest with melanoma and renal cancer, and drug related adverse events were common, including immune related conditions such as pneumonitis [3 fatal], vitiligo, colitis, hepatitis [reversible in all cases], hypophysitis and thyroiditis; ALT elevations occurred in 11 patients [4%] and were greater than 5 times ULN in 2 [1%]).
Brahmer JR, Tykodi SS, Chow LQ, Hwu WJ, Topalian SL, Hwu P, Drake CG, et al. (2012). Safety and activity of anti-PD-L1 antibody in patients with advanced cancer. N Engl J Med. (Among 207 patients with various advanced solid tumors treated with nivolumab given daily for 14 days in 6 week cycles for an average of 12 weeks, durable tumor regression occurred in 6-17% of patients; serious adverse events considered related to therapy occurred in 5%, but no patient had ALT elevations above 5 times ULN).
Gardiner D, Lalezari J, Lawitz E, DiMicco M, Ghalib R, Reddy KR, Chang KM, et al. (2013). A randomized, double-blind, placebo-controlled assessment of BMS-936558, a fully human monoclonal antibody to programmed death-1 (PD-1), in patients with chronic hepatitis C virus infection. PLoS One. (Among 56 patients with chronic hepatitis C treated with a single injection of nivolumab or placebo, decreases in HCV RNA occurred in 11% of both groups, 12% had immune related adverse events and one a transient ALT elevation above 10 times ULN).
Wolchok JD, Kluger H, Callahan MK, Postow MA, Rizvi NA, Lesokhin AM, Segal NH, et al. (2013). Nivolumab plus ipilimumab in advanced melanoma. N Engl J Med. (Among 53 patients with advance melanoma treated with the combination of ipilimumab and nivolumab, the objective response rate was 53% to the optimal dose regimen, but adverse events were common [98%] as were serious adverse events [49%], any ALT elevations [23%] and elevations above 5 times ULN [13%]; lower response rates [20%] and ALT elevations [3%] occurred with sequential therapy).
Weber JS, Kudchadkar RR, Yu B, Gallenstein D, Horak CE, Inzunza HD, Zhao X, et al. (2013). Safety, efficacy, and biomarkers of nivolumab with vaccine in ipilimumab-refractory or -naive melanoma. J Clin Oncol. (Among 90 patients with refractory or naïve melanoma treated with nivolumab in 1 of 3 doses every 2 weeks for 24 weeks, then every 12 weeks with or without a peptide vaccine, response rates were approximately 25% and adverse events were manageable; no mention of ALT elevations or hepatotoxicity).
Ascierto PA, Simeone E, Sileni VC, Pigozzo J, Maio M, Altomonte M, Del Vecchio M, et al. (2014). Clinical experience with ipilimumab 3 mg/kg: real-world efficacy and safety data from an expanded access programme cohort. J Transl Med. (Among 855 patients with melanoma treated with ipilimumab in an expanded access program, 19 [2%] developed “liver toxicity”, which led to stopping therapy in 1 patient and death from hepatitis in another).
Teply BA, Lipson EJ. (2014). Identification and management of toxicities from immune checkpoint-blocking drugs. Oncology (Williston Park). (Clinical review of the toxicities of immune checkpoint blocking drugs such as ipilimumab, pembrolizumab and nivolumab, mentions that elevations of serum aminotransferase elevations should lead to careful exclusion of other causes of liver injury and increased monitoring; that elevations above 3 times ULN should lead to withholding the drug and starting corticosteroids; and, that elevations above 5 times ULN should lead to hospital admission and immediate administration of high doses of corticosteroids).
Tumeh PC, Harview CL, Yearley JH, Shintaku IP, Taylor EJ, Robert L, Chmielowski B, et al. (2014). PD-1 blockade induces responses by inhibiting adaptive immune resistance. Nature. (Analysis of expression of PD-1 and its ligand on CD8+ T cells at the margins of melanoma tumors before and after treatment with pembrolizumab showed that high levels of PD-1 and its ligand are found in responders to therapy).
Ansell SM, Lesokhin AM, Borrello I, Halwani A, Scott EC, Gutierrez M, Schuster SJ, et al. (2015). PD-1 blockade with nivolumab in relapsed or refractory Hodgkin's lymphoma. N Engl J Med. (Among 23 patients with refractory Hodgkin lymphoma treated with nivolumab [3 mg/kg every 2 weeks], objective responses occurred in 87% and 3 patients had drug related serious adverse events, but none were hepatic; no mention of ALT elevations).
Motzer RJ, Rini BI, McDermott DF, Redman BG, Kuzel TM, Harrison MR, Vaishampayan UN, et al. (2015). Nivolumab for metastatic renal cell carcinoma: results of a randomized phase II trial. J Clin Oncol. (Among 168 patients with metastatic renal cell cancer treated with 1 of 3 doses of nivolumab every 3 weeks, objective response rates were 20-22% and ALT elevations occurred in 7 [4%] and were above 5 times ULN in 2 [1%]).
Robert C, Long GV, Brady B, Dutriaux C, Maio M, Mortier L, Hassel JC, et al. Nivolumab in previously untreated melanoma without BRAF mutation. N Engl J Med 2015; 372: 320-30. 25399552 (Among 418 patients with metastatic melanoma [BRAF-] treated with nivolumab or dacarbazine, one year survival was 73% vs 42%, and common side effects of nivolumab were fatigue [20%], pruritus [17%] and nausea [17%]; 2 patients [1%] had ALT elevations above 5 times ULN, 1 requiring corticosteroid therapy).
Rizvi NA, Mazières J, Planchard D, Stinchcombe TE, Dy GK, Antonia SJ, Horn L, et al. (2015). Activity and safety of nivolumab, an anti-PD-1 immune checkpoint inhibitor, for patients with advanced, refractory squamous non-small-cell lung cancer (CheckMate 063): a phase 2, single-arm trial. Lancet Oncol. (Among 117 patients with advanced, refractor NSCLC treated with nivolumab [3 mg/kg every 2 weeks], the objective response rate was 15% and adverse events were common [74%]; no serious adverse events were liver related and ALT elevations [less than 5 times ULN] occurred in only 1 patient [1%]).
Weber JS, D'Angelo SP, Minor D, Hodi FS, Gutzmer R, Neyns B, Hoeller C, et al. (2015). Nivolumab versus chemotherapy in patients with advanced melanoma who progressed after anti-CTLA-4 treatment (CheckMate 037): a randomised, controlled, open-label, phase 3 trial. Lancet Oncol. (Among 272 patients with refractory, advanced melanoma treated with nivolumab, the objective response rate was 32% and adverse events were common [68%] and 2 patients [1%] had ALT elevations above 5 times ULN, resolving with corticosteroid therapy).
Rizvi NA, Hellmann MD, Snyder A, Kvistborg P, Makarov V, Havel JJ, Lee W, et al. (2015). Cancer immunology. Mutational landscape determines sensitivity to PD-1 blockade in non-small cell lung cancer. Science. (Exome sequencing from NSCLC tumors in patients treated with pembrolizumab showed that patients with a durable clinical benefit of therapy typically had higher numbers of nonsynonymous mutations, an association confirmed in a second cohort; mutations were not in the known PD-1 or checkpoint pathways, but likely represented genes that express neo-antigens).
Sharma P, Allison JP. (2015). The future of immune checkpoint therapy. Science. (Commentary and review of the rationale, history, clinical efficacy and mechanism of action of immune checkpoint therapy).
Martin-Liberal J, Furness AJ, Joshi K, Peggs KS, Quezada SA, Larkin J. (2015). Anti-programmed cell death-1 therapy and insulin-dependent diabetes: a case report. Cancer Immunol Immunother. (54 year old woman with melanoma who was treated unsuccessfully with nivolumab and ipilimumab, developed diabetic ketoacidosis after 3 doses of pembrolizumab [anti-GAD positive] having had normal glucose levels before treatment, but also having high risk HLA alleles for type 1 diabetes; no mention of ALT elevations).
Hughes J, Vudattu N, Sznol M, Gettinger S, Kluger H, Lupsa B, Herold KC. (2015). Precipitation of autoimmune diabetes with anti-PD-1 immunotherapy. Diabetes Care. (Description of 5 patients with cancer who had new-onset of insulin dependent diabetes 1 week to 5 months after starting nivolumab [n=4] or pembrolizumab [n=1], 3 with anti-GAD, and all requiring insulin therapy chronically; 3% of patients treated with these agents at this cancer center).
Gettinger SN, Horn L, Gandhi L, Spigel DR, Antonia SJ, Rizvi NA, Powderly JD, et al. (2015). Overall survival and long-term safety of nivolumab (anti-programmed death 1 antibody, BMS-936558, ONO-4538) in patients with previously treated advanced non-small-cell lung cancer. J Clin Oncol. (Among 129 patients with advanced, refractory NSCLC treated with 1 of 3 doses of nivolumab every 2 weeks for up to 96 weeks, objective response rates at 1 year were 42%; serum enzyme elevations occurred in 6 patients [5%] and were above 5 times ULN in one; 2 patients died of suspected treatment-related, immune mediated pneumonitis).
McDermott DF, Drake CG, Sznol M, Choueiri TK, Powderly JD, Smith DC, Brahmer JR, et al. (2015). Survival, durable response, and long-term safety in patients with previously treated advanced renal cell carcinoma receiving nivolumab. J Clin Oncol. (Among 34 patients with advanced renal cell cancer treated with pembrolizumab [1 or 10 mg/kg every two weeks], objective responses occurred in 10 patients [29%], and immune mediated adverse events in 19 [56%], including ALT elevations in 4 patients [12%] which were above 5 times ULN in 1 [3%]).
(2015). Nivolumab (Opdivo) for metastatic melanoma and metastatic NSCLC. Med Lett Drugs Ther. (Concise review of the mechanism of action, efficacy, safety and costs of nivolumab for metastatic melanoma shortly after its approval for this use in the US; mentions that side effects can include immune mediated reactions including hepatitis as well as transient, but marked serum ALT elevations).
Le DT, Uram JN, Wang H, Bartlett BR, Kemberling H, Eyring AD, Skora AD, et al. (2015). PD-1 Blockade in Tumors with Mismatch-Repair Deficiency. N Engl J Med. (Among 41 patients with advanced cancers with or without mismatch repair deficiency, response rates to pembrolizumab were higher in those with mismatch repair deficiency [53%] than in those without [0%]; adverse events occurred in 98% of patients; ALT elevations occurred in 3 [7%] patients and were greater than 5 times ULN in 2 [5%]).
Brahmer J, Reckamp KL, Baas P, Crinò L, Eberhardt WE, Poddubskaya E, Antonia S, et al. (2015). Nivolumab versus Docetaxel in Advanced Squamous-Cell Non-Small-Cell Lung Cancer. N Engl J Med. (Among 272 patients with advanced NSCLC treated with nivolumab or docetaxel, overall one year survival rates were greater with nivolumab [42% vs 24%] and side effects were less, ALT elevations occurring in 2% vs 1%, but were mostly mild and self-limited).
Larkin J, Chiarion-Sileni V, Gonzalez R, Grob JJ, Cowey CL, Lao CD, Schadendorf D, et al. (2015). Combined nivolumab and ipilimumab or monotherapy in untreated melanoma. N Engl J Med. (Among 945 patients with advanced, untreated melanoma treated with checkpoint inhibitors, median progression-free survival was 3 months with ipilimumab, 7 months with nivolumab and 11.5 months with the combination of both, adverse events including ALT elevations also being more common with the combination [any ALT elevation 17.6%, ALT above 5 times ULN 8.3%] than either alone [3.8% and 1.3% for nivolumab vs 3.9% and 1.6% for ipilimumab], almost all resolving with immunosuppressive therapy).
Nishino M, Sholl LM, Hodi FS, Hatabu H, Ramaiya NH. (2015). Anti-PD-1-related pneumonitis during cancer immunotherapy. N Engl J Med. (Summary of 3 patients with melanoma treated with nivolumab [2 also received ipilimumab] who developed severe immune mediated interstitial pneumonitis 7-24 months after starting therapy with diffuse pulmonary ground-glass and reticular opacities, 2 eventually recovering with corticosteroid therapy, one dying after 4 weeks).
Larkin J, Lao CD, Urba WJ, McDermott DF, Horak C, Jiang J, Wolchok JD. (2015). Efficacy and safety of nivolumab in patients with BRAF V600 mutant and BRAF wild-type advanced melanoma: A pooled analysis of 4 clinical trials. JAMA Oncol. (Pooled analysis of 4 clinical trials of 5 doses of nivolumab in 440 adults with advanced melanoma found similar efficacy and safety in tumors with mutant vs wild-type BRAF; no specific mention of ALT elevations or hepatotoxicity).
Narita T, Oiso N, Taketomo Y, Okahashi K, Yamauchi K, Sato M, Uchida S, et al. (2016). Serological aggravation of autoimmune thyroid disease in two cases receiving nivolumab. J Dermatol. (Two patients, 65 and 70 years old, one woman and one man developed thyroid test abnormalities soon after starting nivolumab therapy for metastatic melanoma, having subtle abnormalities before treatment; ALT values remained normal or minimally elevated).
Borghaei H, Paz-Ares L, Horn L, Spigel DR, Steins M, Ready NE, Chow LQ, et al. (2015). Nivolumab versus docetaxel in advanced nonsquamous non-small-cell lung cancer. N Engl J Med. (Among 582 patients with NSCLC treated with nivolumab or docetaxel, the one year overall survival rate was better with nivolumab [51% vs 39%] and overall adverse events were less, and ALT elevations above 5 times ULN occurred in none on nivolumab and 1 on docetaxel).
Motzer RJ, Escudier B, McDermott DF, George S, Hammers HJ, Srinivas S, Tykodi SS, et al. (2015). CheckMate 025 Investigators. Nivolumab versus everolimus in advanced renal-cell carcinoma. N Engl J Med. (Among 831 patients with advanced renal cancer treated with nivolumab or everolimus, median overall survival was better with nivolumab [25 vs 19.6 months] and side effects were less [79% vs 88%]; no mention of ALT elevations or hepatotoxicity).
Abdel-Rahman O, El Halawani H, Fouad M. (2015). Risk of elevated transaminases in cancer patients treated with immune checkpoint inhibitors: a meta-analysis. Expert Opin Drug Saf. (Analysis of publications on checkpoint inhibitors including nivolumab and ipilimumab indicated that therapy was associated with higher rates of ALT elevations).
Hamanishi J, Mandai M, Ikeda T, Minami M, Kawaguchi A, Murayama T, Kanai M, et al. (2015). Safety and antitumor activity of anti-PD-1 antibody, nivolumab, in patients with platinum-resistant ovarian cancer. J Clin Oncol. (Among 20 patients with advanced, refractory ovarian cancer treated with 1 of 2 doses of nivolumab, adverse events were common [95%] and included ALT elevations in 5 patients [25%] which were above 5 times ULN in 1 [5%]).
Davar D, Wilson M, Pruckner C, Kirkwood JM. (2015). PD-1 blockade in advanced melanoma in patients with hepatitis C and/or HIV. Case Rep Oncol Med. (59 year old woman and 47 year old man with metastatic melanoma and combined HIV and hepatitis C infection were treated with pembrolizumab, tolerating therapy with no worsening of liver disease or HIV infection).
(2015). Nivolumab (Opdivo) plus ipilimumab (Yervoy) for metastatic melanoma. Med Lett Drugs Ther. (Concise review of the rationale, clinical efficacy, adverse effects and costs of nivolumab and ipilimumab for metastatic melanoma shortly after approval of this combination in the US; no mention of hepatotoxicity or ALT elevations).
Kanameishi S, Otsuka A, Nonomura Y, Fujisawa A, Endo Y, Kabashima K. (2016). Idiopathic thrombocytopenic purpura induced by nivolumab in a metastatic melanoma patient with elevated PD-1 expression on B cells. Ann Oncol. (79 year old woman with metastatic melanoma developed severe thrombocytopenia after 2 doses of nivolumab [platelet count 2000/µL], having been normal before therapy, ultimately responding to corticosteroids, IVIG and romiplostim; no information given on subsequent course).
Hofmann L, Forschner A, Loquai C, Goldinger SM, Zimmer L, Ugurel S, Schmidgen MI, et al. (2016). Cutaneous, gastrointestinal, hepatic, endocrine, and renal side-effects of anti-PD-1 therapy. Eur J Cancer. (Among 496 patients with metastatic melanoma treated in 15 European centers with either nivolumab or pembrolizumab, 138 [28%] had at least one immune related adverse event including 11 [2%] with hepatitis arising after 1-4 infusions in all but 1, all treated with corticosteroids, 2 needing addition of mycophenolate, 9 resolving and 2 improving, none fatal).
Gelsomino F, Vitale G, D'Errico A, Bertuzzi C, Andreone P, Ardizzoni A. (2017). Nivolumab-induced cholangitic liver disease: a novel form of serious liver injury. Ann Oncol. (79 year old man with NSCLC developed jaundice after 4 infusions of nivolumab [day 62] with bilirubin 10.5, ALT ~480 U/L, Alk P~950 U/L, jaundice resolving 14 weeks after stopping therapy and with corticosteroid treatment, but patient died of progressive cancer shortly thereafter and before Alk P and GGT were completely normal).
Mirza S, Hill E, Ludlow SP, Nanjappa S. (2017). Checkpoint inhibitor-associated drug reaction with eosinophilia and systemic symptom syndrome. Melanoma Res. (46 year old man with melanoma developed fever, rash, eosinophilia with elevations in ALT [115 U/L] and creatinine [1.2 mg/dL] while being treated with ipilimumab and nivolumab, but also shortly after courses of doxycycline and levofloxacin, responding rapidly to corticosteroid therapy).
Spänkuch I, Gassenmaier M, Tampouri I, Noor S, Forschner A, Garbe C, Amaral T. (2017). Severe hepatitis under combined immunotherapy: Resolution under corticosteroids plus anti-thymocyte immunoglobulins. Eur J Cancer. (49 year old woman with metastatic melanoma developed hepatitis after 3 cycles of ipilimumab and nivolumab [bilirubin 5.8 mg/dL, ALT 772 U/L, Alk P 449 U/L], with inadequate response to corticosteroids but eventual response after starting antithymocyte globulin, later tolerating pembrolizumab without recurrence on low doses of prednisone).
Kawakami H, Tanizaki J, Tanaka K, Haratani K, Hayashi H, Takeda M, Kamata K, et al. (2017). Imaging and clinicopathological features of nivolumab-related cholangitis in patients with non-small cell lung cancer. Invest New Drugs. (Among 91 Japanese patients with advanced NSCLC treated with nivolumab, 3 developed severe cholangitis arising after 6, 9 and 12 cycles in 2 women and 1 man, ages 64 to 82 years with marked elevations in Alk P (peak 1769, 1947 and 2996 U/L], modest ALT elevations [144, 101 and 70 U/L], no autoantibodies, and imaging showing localized common bile duct dilatation with distal breaking but no obstruction, hypertrophy of bile duct wall and no intrahepatic duct abnormalities, all with poor or only moderate response to corticosteroids).
Doherty GJ, Duckworth AM, Davies SE, Mells GF, Brais R, Harden SV, Parkinson CA, et al. (2017). Severe steroid-resistant anti-PD1 T-cell checkpoint inhibitor-induced hepatotoxicity driven by biliary injury. ESMO Open. (Three cases of checkpoint inhibitor induced cholestatic liver injury in 2 women and 1 man, ages 47, 59 and 76 years, who developed liver injury after 1-3 cycles of pembrolizumab or nivolumab, one with severe ductopenia who died of liver failure, one with focal ductopenia who eventually recovered, and one with prolonged cholestasis who died of progressive cancer, all with poor or only moderate response to corticosteroids).
Weber JS, Hodi FS, Wolchok JD, Topalian SL, Schadendorf D, Larkin J, Sznol M, et al. (2017). Safety profile of nivolumab monotherapy: a pooled analysis of patients With advanced melanoma. J Clin Oncol. (Among 576 patients with advanced melanoma treated with nivolumab [every two weeks] for an average of 6 months, 4.2% developed liver abnormalities, most commonly ALT elevations [1.9%] but few [0.7%] were above 5 times ULN).
Schadendorf D, Wolchok JD, Hodi FS, Chiarion-Sileni V, Gonzalez R, Rutkowski P, Grob JJ, et al. (2017). Efficacy and safety outcomes in patients with advanced melanoma who discontinued treatment with nivolumab and ipilimumab because of adverse events: a pooled analysis of randomized phase II and III trials. J Clin Oncol. (Among 407 patients with advanced melanoma treated with the combination of ipilimumab and nivolumab for 4 cycles and then nivolumab alone, 156 discontinued therapy because of adverse events, including 13 with liver toxicity, but progression-free survival was similar in those who continued and those who discontinued therapy, largely during the induction period).
El-Khoueiry AB, Sangro B, Yau T, Crocenzi TS, Kudo M, Hsu C, Kim TY, et al. (2017). Nivolumab in patients with advanced hepatocellular carcinoma (CheckMate 040): an open-label, non-comparative, phase 1/2 dose escalation and expansion trial. Lancet. (Among 262 patients with advanced hepatocellular carcinoma [HCC] treated with nivolumab in dose escalation and expansion studies, objective responses were achieved in 15-20% of patients and toxicity was “manageable” with ALT elevations in 15% that were above 5 times ULN in 6%; among 51 patients with HBV all were receiving antiviral prophylaxis and none had HBV reactivation).
Lake AC. (2017). Hepatitis B reactivation in a long-term nonprogressor due to nivolumab therapy. AIDS. (72 year old man with HIV infection, recurrent metastatic lung cancer and anti-HBc without HBsAg was started on dolutegravir and abacavir and then on nivolumab and was found to have acute liver injury 1 month later [bilirubin 0.5 mg/dL, ALT 332 UL, Alk P 205 U/L, HBsAg positive and HBV DNA > 170 million IU/mL], started on tenofovir and later tolerated restarting nivolumab).
Koksal AS, Toka B, Eminler AT, Hacibekiroglu I, Uslan MI, Parlak E. (2017). HBV-related acute hepatitis due to immune checkpoint inhibitors in a patient with malignant melanoma. Ann Oncol. (56 year old man with melanoma and HBsAg in serum developed liver injury 12 weeks after starting ipilimumab [bilirubin 0.7 rising to 1.9 mg/dL, ALT 246 rising to 888 U/L, HBV DNA 244,259 IU/mL], responding to tenofovir and was continued on nivolumab).
Pollack MH, Betof A, Dearden H, Rapazzo K, Valentine I, Brohl AS, Ancell KK, et al. (2018). Safety of resuming anti-PD-1 in patients with immune-related adverse events (irAEs) during combined anti-CTLA-4 and anti-PD1 in metastatic melanoma. Ann Oncol. (Among 80 patients treated with checkpoint inhibitors who developed immune related adverse events requiring discontinuation who were then restarted on therapy, 31 [39%] had recurrence or toxicities requiring discontinuation again, of the 29 who had hepatitis initially, 5 had recurrence on restarting).
Santini FC, Rizvi H, Plodkowski AJ, Ni A, Lacouture ME, Gambarin-Gelwan M, Wilkins O, et al. (2018). Safety and efficacy of re-treating with immunotherapy after immune-related adverse events in patients with NSCLC. Cancer Immunol Res. (Among 482 patients with metastatic or advanced NSCLC treated with checkpoint inhibitors at a single US referral center between 2011 and 2016, 68 [14%] developed a serious immune related adverse event [irAE] that required discontinuation of whom 38 were retreated, of whom 18 had no recurrence, 10 had recurrence of the same irAE, 10 had a new irAE [2 of which were fatal]; restarting therapy appeared to be beneficial only in those who had no tumor response before onset of the first event).
Zarrabi K, Wu S. (2018). Risk of liver toxicity with nivolumab immunotherapy in cancer patients. Oncology. (Meta-analysis of 27 clinical trials of nivolumab cancer chemotherapy found incidence of any ALT elevation to be 5% and ALT elevation above 5 times ULN 1.7%, with higher rates of any ALT elevations in 3 trials of its combination with ipilimumab [24%] vs in 17 trials of nivolumab monotherapy [3.5%]).
Zen Y, Yeh MM. (2018). Hepatotoxicity of immune checkpoint inhibitors: a histology study of seven cases in comparison with autoimmune hepatitis and idiosyncratic drug-induced liver injury. Mod Pathol. (Liver histology from 7 patients with checkpoint inhibitor [CPI] induced hepatitis [4 nivolumab, 2 ipilimumab, arising after 1-6 doses] and classical autoimmune hepatitis showed similar rates of lobular hepatitis, but less confluent necrosis with CPIs and absence of autoantibodies and IgG elevations).
Matsubara T, Nishida T, Higaki Y, Tomita R, Shimakoshi H, Shimoda A, Osugi N, et al. (2018). Nivolumab induces sustained liver injury in a patient with malignant melanoma. Intern Med. (42 year old man with metastatic melanoma developed ALT elevations after 17 cycles [1 year] of nivolumab therapy [ALT initially 380 rising to 693 U/L, Alk P 373 U/L, bilirubin 0.6 mg/dL, ANA negative], with slow response to corticosteroid therapy, ALT falling to near normal by 4 months but remaining mildly elevated after stopping).
Huffman BM, Kottschade LA, Kamath PS, Markovic SN. (2018). Hepatotoxicity after immune checkpoint inhibitor therapy in melanoma: natural progression and management. Am J Clin Oncol. (Among 281 patients with cancer treated with checkpoint inhibitors at the Mayo Clinic over a 5 year period, 17 [6%] developed liver injury within 16-151 [median=52] days of starting [ipilimumab alone in 12, with nivolumab in 2 and pembrolizumab alone in 3], all with ALT elevations [59 to 2355 U/L], often with Alk P elevations [up to 1728 U/L], 6 with jaundice [bilirubin 2.5 to 15.7 mg/dL], all but one treated with corticosteroids, responding in 6 to 56 [median 31] days, 2 requiring a second agent [azathioprine or cycloserine], none fatal).
Postow MA, Sidlow R, Hellmann MD. (2018). Immune-related adverse events associated with immune checkpoint blockade. N Engl J Med. (Review of the clinical features, outcomes, pathogenesis and therapy of immune related adverse events of checkpoint inhibitor therapy).
De Martin E, Michot JM, Papouin B, Champiat S, Mateus C, Lambotte O, Roche B, et al. (2018). Characterization of liver injury induced by cancer immunotherapy using immune checkpoint inhibitors. J Hepatol. (Among 536 patients treated with checkpoint inhibitors, 19 [3.5%] were referred to a liver service for high grade hepatitis and 16 underwent liver biopsy; ages 33 to 84 years, 56% female, injury arising after 1-36 [median=5] weeks and 1-36 [median=2] doses, presenting with fever in 38%, rash in 31%, ALT 266 to 3137 [460] U/L, Alk P 54 to 768 [309] U/L, bilirubin 0.4 to 19 [1.1] mg/dL, enzyme pattern most commonly being mixed, 10 patients treated with corticosteroids and 6 resolving spontaneously and no deaths).
Kashima J, Okuma Y, Shimizuguchi R, Chiba K. (2018). Bile duct obstruction in a patient treated with nivolumab as second-line chemotherapy for advanced non-small-cell lung cancer: a case report. Cancer Immunol Immunother. (63 year old Japanese man with refractory lung adenocarcinoma was found to have a dilated gallbladder without gallstones on routine CT scan of the chest after 4 cycles of nivolumab, subsequently he developed abdominal discomfort and imaging suggesting obstruction of lower end of common bile duct but none found of endoscopic imaging [ALT 92 U/L, Alk P 1543 U/L], improving temporarily with stenting and then more completely with high dose prednisone).
Kuraoka N, Hara K, Terai S, Yatabe Y, Horio Y. (2018). Peroral cholangioscopy of nivolumab-related (induced) ulcerative cholangitis in a patient with non-small cell lung cancer. Endoscopy. (69 year old man with advanced, refractory adenocarcinoma of the lung, developed rash after 3^rd^ course of nivolumab with elevations in ALT and Alk P not responsive to prednisolone, imaging showing hypertrophy and dilatation of extrahepatic bile ducts without obstruction, endoscopy demonstrating yellow plaques and inflammation of biliary duct epithelium resulting in progressive cholestasis and death 3 months later).
Karamchandani DM, Chetty R. (2018). Immune checkpoint inhibitor-induced gastrointestinal and hepatic injury: pathologists' perspective. J Clin Pathol. (Review of the gastrointestinal and hepatic pathology of checkpoint inhibitor induced immune adverse events with acute hepatitis and acute cholangitic patterns found on liver biopsy).
Pandey A, Ezemenari S, Liaukovich M, Richard I, Boris A. (2018). A rare case of pembrolizumab-induced reactivation of hepatitis B. Case Rep Oncol Med. (51 year old man with metastatic lung cancer developed liver injury after 1^st^ dose of pembrolizumab and was found to have reactivation of HBV [bilirubin normal, ALT 528 rising to 994 U/L, Alk P normal, HBsAg positive, HBeAg negative, HBV DNA > 170 million IU/mL], responding to tenofovir therapy, and later restarted on checkpoint inhibitor therapy).
Zhang X, Zhou Y, Chen C, Fang W, Cai X, Zhang X, Zhao M, et al. (2019). Hepatitis B virus reactivation in cancer patients with positive Hepatitis B surface antigen undergoing PD-1 inhibition. J Immunother Cancer. (Among 114 HBsAg-positive Chinese patients undergoing checkpoint inhibitor therapy for advanced malignancies, 6 developed HBV reactivation [1 of 85 on prophylaxis vs 5 of 29 not] after 3-35 [median=18] weeks of therapy with peak ALT 28 to 465 U/L, HBV DNA 1,800 to 60 million IU/mL [all were undetectable at baseline], none with jaundice, 5 treated with rapid improvement, all 6 recovered).
Abu-Sbeih H, Tran CN, Ge PS, Bhutani MS, Alasadi M, Naing A, Jazaeri AA, et al. (2019). Case series of cancer patients who developed cholecystitis related to immune checkpoint inhibitor treatment. J Immunother Cancer. (Among 4253 patients treated with checkpoint inhibitors at the MD Anderson Cancer Center between 2010 and 2018, 25 [0.6%] developed acalculous cholecystitis attributed to the immunotherapy most frequently with anti-CTLA-4 agents alone [1.6%], than anti-PD-1/PD-L1 [0.4%] and combination [0.9%], mean age of patients was 60 years, 60% male, 64% white, median peak ALT 55 U/L, bilirubin 1.4 mg/dL, 20% underwent cholecystectomy, all recovered, 10 [40%] restarted therapy, all without recurrence).
Fouchard M, Jantzem H, Quere G, Descourt R, Robinet G, Poureau PG. (2019). Three cases of immune cholangitis related to anti-programmed cell death and programmed cell death ligand agents for the treatment of non-small cell lung cancer. Eur J Cancer. (3 patients with metastatic lung cancer developed cholangitis 2, 4 and 9 months after starting checkpoint inhibitor therapy [nivolumab, durvalumab/tremelimumab, pembrolizumab] presenting with abdominal pain and fever, modest ALT but marked Alk P elevations and minimal jaundice; imaging showing biliary dilation and thickening of the gallbladder wall, biopsies showing inflammation with CD8+ lymphocytes, and slow clinical response to corticosteroids but long-term remission in cancer).
Oda H, Ishihara M, Miyahara Y, Nakamura J, Kozuka Y, Iwasa M, Tsunoda A, et al. (2019). First case of cytokine release syndrome after nivolumab for gastric cancer. Case Rep Oncol. (43 year old man with advanced, refractory gastric cancer developed high fever, fatigue and jaundice 8 days after starting nivolumab [ALT 31 rising to ~160 U/L, Alk P 598 rising to 1400 U/L, bilirubin 3.7 rising to 8 mg/dL], with concurrent elevations in serum levels of interferon gamma, TNF alpha and ferritin, responding minimally to corticosteroid therapy and dying before recovery of progressive cancer).
Zhang HC, Luo W, Wang Y. (2019). Acute liver injury in the context of immune checkpoint inhibitor-related colitis treated with infliximab. J Immunother Cancer. (79 year old man with metastatic prostate cancer treated 3 cycles of nivolumab and ipilimumab developed corticosteroid-refractory immune mediated enterocolitis and was treated with a single infusion of infliximab and one month later developed jaundice [bilirubin 7.5 mg/dL, ALT 291 U/L, Alk P 677 U/L, ANA negative], which was attributed to infliximab and eventually resolved without corticosteroid therapy).
Kopecký J, Kubecek O, Geryk T, Podhola M, Ziaran M, Priester P, Hanisova M, et al. Hepatic injury induced by a single dose of nivolumab - a case report and literature review. Klin Onkol. 2019 ;32(:133-138. (38 year old female with metastatic melanoma developed liver injury 14 days after an initial infusion of nivolumab [bilirubin 6.1 rising to 21 mg/dL, ALT 720 rising to 3012 U/L, GGT >2000 U/L], with only a partial response to corticosteroids and mycophenolate and death from progressive disease 2 months later).
Sawada K, Shonaka T, Nishikawa Y, Hasegawa K, Hayashi H, Hasebe T, Nakajima S, et al. (2019). Successful treatment of nivolumab-related cholangitis with prednisolone: a case report and review of the literature. Intern Med. (76 year old man with advanced gastric cancer developed marked Alk P elevations after 4 cycles of nivolumab [bilirubin 0.8 mg/dL, ALT 68 U/L, Alk P 2427 U/L], biopsy showing eosinophilic cholangitis and prednisolone therapy followed by a rapid improvement).
Cheung V, Gupta T, Payne M, Middleton MR, Collier JD, Simmons A, Klenerman P, et al. (2019). Immunotherapy-related hepatitis: real-world experience from a tertiary centre. Frontline Gastroenterol. (Among 453 patients treated with checkpoint inhibitors for cancer between 2022 and 2018, 20 [4%] developed immune related hepatitis, with highest rates with the combination of ipilimumab and nivolumab, 18 treated with immunosuppression using corticosteroids, 8 with addition of mycophenolate and 2 with infliximab, none fatal).
Zen Y, Yeh MM. (2019). Checkpoint inhibitor-induced liver injury: A novel form of liver disease emerging in the era of cancer immunotherapy. Semin Diagn Pathol. (Liver histology from 7 patients with checkpoint inhibitor [CPI] induced hepatitis [4 nivolumab, 2 ipilimumab, arising after 1-6 doses] and classical autoimmune hepatitis showed similar rates of lobular hepatitis, but less confluent necrosis with CPIs and absence of autoantibodies and IgG elevations).
Vozy A, De Martin E, Johnson DB, Lebrun-Vignes B, Moslehi JJ, Salem JE. (2019). Increased reporting of fatal hepatitis associated with immune checkpoint inhibitors. Eur J Cancer. (Review of the VigiBase registry of adverse drug reactions through September 2018 identified 531 cases of immune related hepatitis, 85% due to CPIs alone with an increase in fatality rate over time, being 14% between 2011 to 2016 and 34% in 2017-2018, time to onset median of 42 days, arising after 1-4 courses [median=2] and with concurrent other organ immune related injury in 31%, usually thyroid or skin).
Zhang D, Hart J, Ding X, Zhang X, Feely M, Yassan L, Alpert L, et al. (2019). Histologic patterns of liver injury induced by anti-PD-1 therapy. Gastroenterol Rep (Oxf). (Liver histology in 8 cases of immune mediated liver injury after monoclonal anti-PD-1 therapy revealed a lobular hepatitis without features of autoimmune hepatitis).
Imoto K, Kohjima M, Hioki T, Kurashige T, Kurokawa M, Tashiro S, Suzuki H, et al. (2019). Clinical features of liver injury induced by immune checkpoint inhibitors in Japanese patients. Can J Gastroenterol Hepatol. (Among 343 Japanese patients with cancer treated with checkpoint inhibitors, 56 [16%] developed evidence of liver injury, arising after 21-94 [median=46] days, with initial ALT 39 to 136 [mean 60] U/L, Alk P 263 to 857 [471] U/L, bilirubin 0.4 to 1.0 [0.7] mg/dL, and thus a cholestatic pattern was found in most patients, and there was a low rate of high grade liver injury [3.2%] and no fatalities).
Onoyama T, Takeda Y, Yamashita T, Hamamoto W, Sakamoto Y, Koda H, Kawata S, et al. (2020). Programmed cell death-1 inhibitor-related sclerosing cholangitis: a systematic review. World J Gastroenterol. (Review of literature on secondary sclerosing cholangitis due to anti-PD-1/PD-L1 therapy identified 31 cases with male:female ratio of 2:1, median age 67 [range 43-89] years, arising after a median of 5.5 [range 1-27] cycles of nivolumab [19], pembrolizumab [10], avelumab [1], or durvalumab [1], with median bilirubin 0.8 [0.3-15.9] mg/dL, ALT 125 [31-1536] U/L, AST 129 [49-961] U/L, Alk P 1543 [237-5066] U/L, GGT 452 [114-2094] U/L, cholangiography demonstrating biliary dilation without obstruction [77%], hypertrophy of the extrahepatic biliary tree [90%], and biliary strictures [30%] and biopsy demonstrating CD8+ infiltrates around bile ducts, and adequate response to corticosteroids in only 11%).
Zen Y, Chen YY, Jeng YM, Tsai HW, Yeh MM. (2020). Immune-related adverse reactions in the hepatobiliary system: second-generation check-point inhibitors highlight diverse histological changes. Histopathology. (Description of 10 cases of second generation checkpoint inhibitor induced immune liver injury mentions 3 patterns, hepatocellular, cholestatic and granulomatous injury, the cholestatic form often with a delayed latency and poor response to corticosteroids).
Peeraphatdit TB, Wang J, Odenwald MA, Hu S, Hart J, Charlton MR. (2020). Hepatotoxicity from immune checkpoint inhibitors: a systematic review and management recommendation. Hepatology. (Review of the clinical features, biochemical findings, histology, pathogenesis, diagnosis and management of immune related liver injury due to the checkpoint inhibitors).
Miller ED, Abu-Sbeih H, Styskel B, Nogueras Gonzalez GM, Blechacz B, Naing A, et al. (2020). Clinical characteristics and adverse impact of hepatotoxicity due to immune checkpoint inhibitors. Am J Gastroenterol. (Among 5762 recipients of checkpoint inhibitor therapy of cancer at the MD Anderson Cancer Center between 2010 and 2018, 433 [8%] developed ALT levels and 100 had levels above 5 times ULN [2%), the rate being 8% with combination therapy, 1.7% with anti-CTLA agents and 1.1% with PD-1 and PD-L1 blockers, the abnormalities arising after a median 59 days; all had the checkpoint inhibitor therapy held, 67 received corticosteroids [for a median of 43 days], 3 with mycophenolate, and 31 were rechallenged after resolution of the hepatitis, of whom 8 [26%] had a recurrence).
Mathew Thomas V, Bindal P, Ann Alexander S, McDonald K. (2020). Nivolumab-induced hepatitis: A rare side effect of an immune checkpoint inhibitor. J Oncol Pharm Pract. (74 year old woman with recurrent, metastatic renal cell carcinoma developed jaundice 2 weeks after starting nivolumab [bilirubin 2 mg/dL, ALT 112 U/L, Alk P not given] and was treated with high doses of corticosteroids which led to improvement, but she died shortly thereafter of gastrointestinal bleeding and multiorgan failure ).
Nordness MF, Hamel S, Godfrey CM, Shi C, Johnson DB, Goff LW, O'Dell H, et al. (2020). Fatal hepatic necrosis after nivolumab as a bridge to liver transplant for HCC: Are checkpoint inhibitors safe for the pretransplant patient?. Am J Transplant. (65 year old man with cirrhosis due to successfully treated chronic hepatitis C and hepatocellular carcinoma on long term nivolumab therapy underwent liver transplantation but developed severe hepatic necrosis starting on post-transplant day 5 [AST 6,000 rising to 19,000 U/L, bilirubin 2.0 rising to 17.0 mg/dL and INR to 10], leading to multiorgan failure and death).
Sawada K, Hayashi H, Nakajima S, Hasebe T, Fujiya M, Okumura T. (2020). Non-alcoholic fatty liver disease is a potential risk factor for liver injury caused by immune checkpoint inhibitor. J Gastroenterol Hepatol. (Among 135 patients with cancer treated with nivolumab or pembrolizumab, 8 developed immune mediated hepatitis of whom 3 [37.5%] had preexisting chronic liver disease versus 14 of the total [10.3%]).
Anugwom C, Leventhal T. (2020). Nivolumab-induced autoimmune-like cholestatic hepatitis in a liver transplant recipient. ACG Case Rep J. (62 year old man with alcohol and HCV related cirrhosis and HCC underwent liver transplantation but had recurrence of HCC and de novo metastatic NSCLC after transplant, which was refractory to conventional chemotherapy and who developed severe cholestatic hepatitis within 2 months of starting nivolumab [bilirubin 8.3 rising to 24 mg/dL, ALT 1265 U/L, Alk P 813 U/L], with subsequent infection, multiorgan failure and gastrointestinal bleeding and death within two weeks of presentation).
Kitagataya T, Suda G, Nagashima K, Katsurada T, Yamamoto K, Kimura M, Maehara O, et al. (2020). Prevalence, clinical course, and predictive factors of immune checkpoint inhibitor monotherapy-associated hepatitis in Japan. J Gastroenterol Hepatol. (Among 202 patients with cancer treated with checkpoint inhibitors at a single referral center in Japan, 17 [8.5%] developed immune related hepatitis, which was severe in 8 [4.5%] often requiring corticosteroids, 2 receiving mycophenolate as well, but none died).
Ruggiero R, Fraenza F, Scavone C, di Mauro G, Piscitelli R, Mascolo A, Ferrajolo C, et al. (2020). Immune checkpoint inhibitors and immune-related adverse drug reactions: data from Italian Pharmacovigilance Database. Front Pharmacol. (Among 2088 safety reports of check point inhibitors enrolled in an Italian pharmacovigilance registry, 801 were immune related including gastrointestinal [33%], skin [17%] and liver [2.7%] due to nivolumab [70%], pembrolizumab [11%], ipilimumab [15%], atezolizumab [4%] and avelumab [<1%]).
Riveiro-Barciela M, Barreira-Díaz A, Vidal-González J, Muñoz-Couselo E, Martínez-Valle F, Viladomiu L, Mínguez B, et al. (2020). Immune-related hepatitis related to checkpoint inhibitors: clinical and prognostic factors. Liver Int. (Among 414 patients treated with checkpoint inhibitors, 28 developed high grade liver injury but 19 were considered mild, 7 moderate, 1 severe and 1 fatal).
Vitale G, Lamberti G, Comito F, Di Nunno V, Massari F, Morelli MC, Ardizzoni A, et al. (2020). Anti-programmed cell death-1 and anti-programmed cell death ligand-1 immune-related liver diseases: from clinical pivotal studies to real-life experience. Expert Opin Biol Ther. (Review of the hepatic complications of anti-PD-1 and anti-PD-L1 checkpoint inhibitors that includes immune mediated hepatitis [typically panlobular inflammation and injury], small and large duct cholangitis [similar to primary biliary and sclerosing cholangitis], immune mediated cholecystitis, nodular regenerative hyperplasia and vanishing bile duct syndrome).
Kitagataya T, Suda G, Nagashima K, Katsurada T, Yamamoto K, Kimura M, Maehara O, et al. (2020). Prevalence, clinical course, and predictive factors of immune checkpoint inhibitor monotherapy-associated hepatitis in Japan. J Gastroenterol Hepatol. (Among 202 patients with cancer treated with checkpoint inhibitors at a single referral center in Japan, 17 [8.5%] developed immune related hepatitis which was severe in 8 [4.5%], often requiring corticosteroids, 2 receiving mycophenolate as well, but none died).
Mizuno K, Ito T, Ishigami M, Ishizu Y, Kuzuya T, Honda T, Kawashima H, et al. (2020). Real world data of liver injury induced by immune checkpoint inhibitors in Japanese patients with advanced malignancies. J Gastroenterol. (Among 546 patients with advanced malignancies treated with checkpoint inhibitors at two Japanese referral centers between 2014 and 2019, high grade, immune mediated liver injury occurred in 29 [5%], mean age 69 years, 73% male, mean onset 52 [range 1-273] days, after 3 [1-15] doses of ipilimumab [6%], nivolumab [54%], pembrolizumab [30%], atezolizumab [6%], durvalumab [2.4%], combination [1.3%], presenting with hepatocellular [21%], cholestatic [59%] or mixed [21%] enzyme elevations, 4 with cholangitis and biliary dilatation without obstruction, only 1 case fatal; predictive factors for injury included ipilimumab [hazard ratio 4.2]).
Lee PC, Chao Y, Chen MH, Lan KH, Lee IC, Hou MC, Huang YH. (2020). Risk of HBV reactivation in patients with immune checkpoint inhibitor-treated unresectable hepatocellular carcinoma. J Immunother Cancer. (Among 62 Taiwanese patients with HBsAg or anti-HBc without HBsAg treated with checkpoint inhibitors for advanced HCC, reactivation of HBV rose in none of 56 given prophylaxis vs 1 of 6 not given antiviral prophylaxis: the one case in an HBsAg positive patient with HBV DNA 8960 IU/mL at baseline rising to 168,000 IU/mL, peak ALT 174U/L, bilirubin 5.2 mg/dL, resolving with tenofovir therapy).
Wong GL, Wong VW, Hui VW, Yip TC, Tse YK, Liang LY, Lui RN, et al. (2021). Hepatitis flare during immunotherapy in patients with current or past hepatitis B virus infection. Am J Gastroenterol. (Among 990 patients in Hong Kong with advanced malignancies treated with checkpoint inhibitors between 2014 and 2019 [397 HBsAg positive, 482 with anti-HBc or anti-HBs, 111 negative for both at baseline], 39% of HBsAg-positive vs 30% of HBsAg-negative patients developed ALT elevations during therapy, but only two cases [both HBsAg positive and on prophylaxis] were due to HBV reactivation).
Cho YA, Han JM, Kang SY, Kim DC, Youn YJ, Choi KH, Gwak HS. (2021). Analysis of risk factors for hepatotoxicity induced by immune checkpoint Inhibitors. J Immunother. (Among 194 patients with cancer treated with checkpoint inhibitors at two Korean referral centers, 125 [64%] developed liver test abnormalities, more frequently in younger patients vs older [30-50 years - 80% vs 50-70 years - 72%, and >70 years - 50%] and in men than women [68% vs 58%]).
Gauci ML, Baroudjian B, Bédérède U, Zeboulon C, Delyon J, Allayous C, Madelaine I, et al., PATIO group. (2021). Severe immune-related hepatitis induced by immune checkpoint inhibitors: Clinical features and management proposal. Clin Res Hepatol Gastroenterol. (Among 339 patients treated at a single French referral center with checkpoint inhibitors, 21 [6.2%] developed high grade liver toxicity, including 8% [7/86] receiving ipilimumab, 3% [3/105] nivolumab, 1% [1/122] pembrolizumab and 38% [10/26] combination therapy; 13 patients received corticosteroids, all except one with severe biliary lesions recovered and 8 restarted therapy none of whom relapsed).
Yoshikawa Y, Imamura M, Yamaoka K, Kosaka Y, Murakami E, Morio K, Fujino H, et al. (2021). A case with life-threatening secondary sclerosing cholangitis caused by nivolumab. Clin J Gastroenterol. (75 year old man with metastatic NSCLC developed marked liver abnormalities after 3 cycles of nivolumab [bilirubin 0.6 mg/dL, ALT 162 U/L, Alk P 1721 U/L, ANA negative] with biliary imaging showing diffuse dilation of the common bile duct and multifocal stenosis, with progressive cholestatic liver injury and death from liver failure despite therapy with corticosteroids and ursodiol).
Au M, Body A, Mant A, Nicoll A. (2021). Checkpoint inhibitor induced steroid refractory drug-induced liver injury. Intern Med J. (75 year old man with metastatic melanoma developed ALT elevations [peak 451 U/L] starting 4 weeks after starting ipilimumab and nivolumab, treated with corticosteroids with a prompt improvement but relapse once prednisone was tapered [ALT 647 U/L], which responded with addition of mycophenolate).
Ortland I, Mirjalili M, Kullak-Ublick GA, Peymani P. (2021). Drug-induced liver injury in Switzerland: an analysis of drug-related hepatic disorders in the WHO pharmacovigilance database VigiBase™ from 2010 to 2020. Swiss Med Wkly. (Among 2042 cases of drug induced liver injury reported from Switzerland to VigiBase between 2010 and 2020, average age 57 years, males and females similar proportions, 10% were fatal and the most common causes included acetaminophen [5.8%], amoxicillin/clavulanate 3.1%, esomeprazole [2.0%], atorvastatin [1.9%], and nivolumab [1.3%]).
Yamamoto A, Yano Y, Ueda Y, Yasutomi E, Hatazawa Y, Hayashi H, Yoshida R, et al. (2021). Clinical features of immune-mediated hepatotoxicity induced by immune checkpoint inhibitors in patients with cancers. J Cancer Res Clin Oncol. (Among 250 patients with cancer treated with checkpoint inhibitors, 21 [9.5%] developed immune mediated liver injury, most frequently with ipilimumab [60%], ipilimumab and nivolumab [57%] compared to nivolumab alone [7%] or pembrolizumab [3%], and rates were higher in patients with melanoma [35%] compared to renal cell cancer [10%] and others).
Aya F, González-Navarro EA, Martínez C, Carcelero E, Arance A. (2021). Safe anti-programmed cell death-1 rechallenge with antibody switching after immune-related adverse events: brief communication. Immunotherapy. (68 year old woman with metastatic melanoma developed ALT elevations [215 U/L] after an initial dose of nivolumab, which resolved rapidly with prednisone therapy and she was later tolerated pembrolizumab without recurrent hepatic injury).
da Silva JA, Falcão D, Cardoso C, Pires AL, Araújo A, Castro-Poças F. (2021). Hepatic immune-mediated adverse effects of immune checkpoint inhibitors: analysis of real-life experience. Ann Hepatol. (Among 151 patients treated with checkpoint inhibitors, 8 [5%] developed liver injury, 5 due to metastases and 3 from immune mediated hepatitis, 2 from nivolumab and 1 pembrolizumab, with latency of 84 days, all three cholestatic and responding to immunosuppression).
Arai K, Matsuda M, Nakayasu H, Meguro S, Kurokami T, Kubota A, Iwasaki T, et al. (2021). Nivolumab-induced liver injury with a steroid-refractory increase in biliary enzymes, in a patient with malignant mesothelioma: an autopsy case report. Clin Case Rep. (75 year old man with refractory, advanced mesothelioma, developed liver injury during a second cycle of nivolumab [ALT 397 U/L, Alk P 272 U/L, bilirubin 0.4 to 0.7 mg/dL] who had progressive liver injury despite immunosuppression).
Mustafayev K, Torres H. Hepatitis B virus and hepatitis C virus reactivation in cancer patients receiving novel anticancer therapies. Clin Microbiol Infect. 2022: S1198-743X (22)00119-7. (Review of the literature on reactivation of HBV and HCV in patients on “novel” anticancer therapy concludes that reactivation can occur with checkpoint inhibitor therapy, but largely among HBsAg positive patients and only rarely in patients with resolved hepatitis B).
Yoo S, Lee D, Shim JH, Kim KM, Lim YS, Lee HC, Yoo C, et al. (2022). Risk of hepatitis B virus reactivation in patients treated with immunotherapy for anti-cancer treatment. Clin Gastroenterol Hepatol. (Among 3,465 patients with advanced malignancies treated with checkpoint inhibitors between 2015 and 2020 at a single referral center in Korean, 511 [15%] were HBsAg positive at baseline, reactivation of HBV occurred in 5 of 511 [1%] HBsAg positive vs none of 2,954 HBsAg negative patients, arising in 2 of 464 [0.4%] patients given prophylaxis [both having stopped antivirals] vs 3 of 47 not given prophylaxis [6.4%]; reactivation arising after 3-141 weeks [median=54 weeks] of nivolumab [n=2], pembrolizumab [n=2] or ipilimumab and nivolumab [n=1] treatment, ALT peak 53 to 1768 IU/mL, HBV DNA 6,100 to 3.9 million IU/mL, resolving with 2 to 6 weeks of starting antiviral therapy).

## OTHER REFERENCE LINKS

1 Recent References on Nivolumab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Nivolumab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Nivolumab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Nivolumab)